# Lemborexant

## OVERVIEW

### Introduction

Lemborexant is an orexin receptor antagonist used for the treatment of insomnia and sleep disorders. Lemborexant therapy is associated with rare occurrence of transient serum enzyme elevations but has not been implicated in cases of clinically apparent liver injury.

### Background

Lemborexant (lem” boe rex' ant) is an orexin receptor antagonist which is used to treat insomnia. Central nervous system neurons with orexin receptors are involved in wakefulness and are inactive during sleep. Engagement of the orexin receptor results in wakefulness, and loss of the receptor can result in excessive daytime sleepiness and narcolepsy. Inhibition of orexin receptor signaling using lemborexant has been shown to shorten the time to falling asleep and to prolong sleep in patients with sleep-onset and sleep-maintenance insomnia. Lemborexant was approved for use in the United States in 2019, the second such orexin based drug approved for chronic insomnia (the first being suvorexant). Lemborexant is available in tablets of 5 and 10 mg under the brand name Dayvigo. The recommended dose is 5 mg taken orally within 30 minutes of bedtime. The dose can be increased to 10 mg. Side effects are few, but may include daytime somnolence, fatigue, dizziness, headache and vivid or abnormal dreams. Rare side effects include sleep paralysis, cataplexy, nightmares, excessive daytime sleepiness, worsening of depression and suicidal ideation and behaviors. Lemborexant can also decrease respiratory function and should be used with caution in persons with respiratory illnesses. Lemborexant, like other orexin antagonists, is classified as a Schedule 4 controlled substance, meaning that it has a low potential for abuse or dependence but has an approved medical use.

### Hepatotoxicity

In several clinical trials, lemborexant was found to be well tolerated, with serum ALT elevations above 3 times the upper limit of normal in less than 1% of treated subjects and with similar rates in placebo recipients. The elevations were transient and asymptomatic, none required dose modification or discontinuation, and none were associated with a simultaneous elevation in serum bilirubin. Thus, in the registration trials of lemborexant, there were no reports of clinically apparent liver injury. Since its approval and more widespread use, lemborexant has been available has not been implicated in causing cases of clinically apparent liver injury.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which lemborexant might cause liver injury is unknown. Lemborexant is metabolized by the cytochrome P450 system (predominantly CYP3A4) and the dose may need to be altered in patients taking strong inhibitors (decreasing dose) or inducers (increasing dose) of the enzymes. The relative lack of serious liver related adverse events is probably due to the low doses used and its uncommon, intermittent use.

Drug Class: Sedatives and Hypnotics, Drugs for Insomnia

Other Orexin Receptor Antagonists: Daridorexant, Suvorexant

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Lemborexant – Dayvigo®

DRUG CLASS

Sedatives and Hypnotics

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Lemborexant)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Lemborexant | 1369764-02-2 | C22-H20-F2-N4-O2

## ANNOTATED BIBLIOGRAPHY

References updated: 5 February 2025

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 731-4. (Expert review of hepatotoxicity published in 1999; lemborexant and the orexin receptor antagonists are not discussed).
Larrey D, Ripault MP. Anxiolytic agents. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 455-6. (Review of hepatotoxicity of hypnotics and sedatives discusses benzodiazepines, buspirone and valerian, all of which have been linked to rare cases of liver injury; suvorexant and orexin receptor antagonists are not discussed).
Mihic SJ, Mayfield J, Harris RA. Hypnotics and sedatives. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 339-354. (Textbook of pharmacology and therapeutics discusses suvorexant but not lemborexant).
FDA. Multi-Discipline Review. 2019. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2019/212028Orig1s000MultidisciplineR.pdf (FDA website with product labels and multiple disciplinary reviews that supported approval of lemborexant in the US, mentions that there were no deaths, no evidence of abuse or diversion, no hepatic serious adverse events, no discontinuations for hepatic events, and no significant shift or change in serum enzyme levels during therapy, no instance of ALT elevation with jaundice, and in registration trials, ALT elevations of more than 3 times ULN arose in 0.6% of lemborexant and 0.6% of placebo recipients).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 82 [9%] were attributed to agents active in the central nervous system, but none were sedatives or sleeping aids). 25754159
Drugs for insomnia. Med Lett Drugs Ther 2015; 57(1472): 95-8. (Concise review of the mechanism of action, efficacy, safety and costs of drugs for insomnia including benzodiazepine receptor agonists, benzodiazepines, melatonin receptor agonists, orexin receptor antagonists such as suvorexant and other agents including nonprescription and herbal products; no mention of ALT elevations or hepatotoxicity). 26147892
Murphy P, Moline M, Mayleben D, Rosenberg R, Zammit G, Pinner K, Dhadda S, et al. Lemborexant, a dual orexin receptor antagonist (DORA) for the treatment of insomnia disorder: results from a Bayesian, adaptive, randomized, double-blind, placebo-controlled study. J Clin Sleep Med. 2017;13: 1289-1299. (Among 291 adults with insomnia treated with lemborexant [1, 2.5, 5, 10, 15 or 25 mg] vs placebo once nightly for 15 days, doses of 2.5 to 10 mg yielded the optimal balance of efficacy vs next morning residual sleepiness [~3% vs 22% at highest doses], and there were “no clinically important differences” between drug and placebo treatment in blood chemistry results). 29065953
Rosenberg R, Murphy P, Zammit G, Mayleben D, Kumar D, Dhadda S, Filippov G, et al. Comparison of lemborexant with placebo and zolpidem tartrate extended release for the treatment of older adults with insomnia disorder: a phase 3 randomized clinical trial. JAMA Netw Open. 2019;2:e1918254. (Among 1006 older adults with insomnia, treated with study drugs once nightly for 1 month, time to sleep onset and sleep maintenance were improved more with lemborexant [5 or 10 mg] than zolpidem or placebo, and adverse events were largely mild-to-moderate, with no treatment related serious adverse events, no deaths and “no notable findings were reported for clinical laboratory tests”). 31880796
Scott LJ. Lemborexant: first approval. Drugs. 2020;80:425-432. (Review of the mechanism of action, history of development, pharmacology, clinical efficacy and safety of lemborexant, shortly after its approval for treatment of insomnia in the US, does not mention ALT elevations or hepatotoxicity). 32096020
Lemborexant (Dayvigo) for insomnia. Med Lett Drugs Ther. 2020;62(1601):97-100. (Concise review of the mechanism of action, clinical efficacy, safety and costs of lemborexant, mentions side effects of somnolence, headaches, abnormal dreams, depression, suicidal ideation and sleep paralysis and cataplexy, but no mention of ALT elevations or hepatotoxicity). 32724021
Kärppä M, Yardley J, Pinner K, Filippov G, Zammit G, Moline M, Perdomo C, et al. Long-term efficacy and tolerability of lemborexant compared with placebo in adults with insomnia disorder: results from the phase 3 randomized clinical trial SUNRISE 2. Sleep. 2020;43:zsaa123. (Among 949 adults with insomnia treated with lemborexant [5 or 10 mg] vs placebo for 6 months, improvements in time to sleep onset and sleep maintenance were greater with lemborexant and overall adverse event rates were similar, except for somnolence [4.1% and 8.6% vs 1.6%] and fatigue [3.8% and 3.5% vs 0.3%], and there were “no clinically important mean changes in … chemistry laboratory parameters” while the incidence of abnormal values was low and similar in the three groups). 32585700
Muehlan C, Vaillant C, Zenklusen I, Kraehenbuehl S, Dingemanse J. Clinical pharmacology, efficacy, and safety of orexin receptor antagonists for the treatment of insomnia disorders. Expert Opin Drug Metab Toxicol. 2020;16:1063-1078. (Review of the role of orexin in sleep and wakefulness, and the mechanism of action, pharmacology, clinical efficacy and safety of orexin receptor antagonists including suvo-, lembo-, darido- and seltorexant, all of which have similar side effects but are generally “well tolerated”). 32901578
Moline M, Thein S, Bsharat M, Rabbee N, Kemethofer-Waliczky M, Filippov G, Kubota N, et al. Safety and efficacy of lemborexant in patients with irregular sleep-wake rhythm disorder and Alzheimer's disease dementia: results from a phase 2 randomized clinical trial. J Prev Alzheimers Dis. 2021;8:7-18. (Among 62 adults with Alzheimer disease and irregular sleep-wake rhythm disorder treated with lemborexant [2.5, 5, 10 or 15 mg] vs placebo for 4 weeks, measures of restlessness and circadian rhythm variables improved with lemborexant, and there were no serious adverse events or treatment related adverse events leading to discontinuation; no mention of ALT or laboratory test results). 33336219
Yardley J, Kärppä M, Inoue Y, Pinner K, Perdomo C, Ishikawa K, Filippov G, et al. Long-term effectiveness and safety of lemborexant in adults with insomnia disorder: results from a phase 3 randomized clinical trial. Sleep Med. 2021;80:333-342. (Among 949 adults with insomnia enrolled in a randomized, placebo-control trial of lemborexant for 6 months followed by open label drug for a total of 12 months, improvements in time to sleep onset, sleep maintenance and self-reported sleep quality were maintained, adverse event rates tended to decrease with continued therapy, and “there were no clinically significant findings for any…chemistry laboratory parameter”). 33636648
Preskorn SH. Comparative pharmacology of the 3 marketed dual orexin antagonists-daridorexant, lemborexant, and suvorexant-part 2. principal drug metabolizing enzyme, drug-drug interactions, and effects of liver and renal impairment on metabolism. J Psychiatr Pract. 2023;29:38-41. (Review of the pharmacokinetics of the 3 orexin antagonists in clinical use, including suvo-, lembo-, and daridorexant, mentions that they have similar chemical structures and similar metabolism by CYP 3A4, with only minor differences in susceptibility to inducers and inhibitors of CYP 3A4). 36649550
Drugs for chronic insomnia. Med Lett Drugs Ther. 2023;65:1-6. (Concise description of drugs approved for use in chronic insomnia including relative efficacy, safety and costs, mentions that orexin receptor inhibitors improve latency to falling asleep by 5-10 minutes and duration of sleep to waking by 15-25 minutes compared to placebo and that the most common adverse events are somnolence, fatigue, headache, and abnormal dreams; no mention of ALT elevations or hepatotoxicity). 36630579
Pan B, Ge L, Lai H, Hou L, Tian C, Wang Q, Yang K, et al. The comparative effectiveness and safety of insomnia drugs: a systematic review and network meta-analysis of 153 randomized trials. Drugs. 2023;83:587-619. (Systematic review of the literature on the safety of drugs for insomnia identified 61 trials with 25,093 patients, and while the frequency of common adverse events varied, “with respect to serious and drug-related adverse events, there were no differences among the drugs’; no mention of liver related adverse events). 36947394

## OTHER REFERENCE LINKS

1. Recent References on Lemborexant: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Lemborexant+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Lemborexant: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Lemborexant)